# Lumasiran

## OVERVIEW

### Introduction

Lumasiran is a synthetic small interfering RNA molecule directed against the mRNA of hydroxyacid oxidase 1 that is used to treat the rare genetic disease primary hyperoxaluria type 1. Lumasiran has not been linked to serum aminotransferase elevations during therapy or to instances of clinically apparent liver injury with symptoms or jaundice.

### Background

Lumasiran (loo” ma sir’ an) is a synthetic, double-stranded, small interfering RNA (siRNA) directed against the mRNA of hydroxyacid oxidase 1 (HAO1), an enzyme made in the liver that decreases the production of oxalate, a relatively insoluble molecule that is not metabolized further and is excreted in the kidneys. Lumasiran was developed to treat primary hyperoxaluria type 1, a rare autosomal recessive disease marked by excessive production of oxalate due to a deficiency in the peroxisomal enzyme alanine-glyoxylate aminotransferase, which converts glyoxylate (the precursor of oxalate) to glycine. As a result, children with primary hyperoxaluria type 1 produce excessive oxalate in the liver which overwhelms the capacity of the kidney for excretion and results in formation of insoluble calcium oxalate crystals leading to nephrocalcinosis, recurrent kidney stones and progressive renal damage. With renal dysfunction, oxalate begins to accumulate in other organs causing damage to bone, skin, vascular endothelium, heart, eye and brain. The clinical manifestations of primary hyperoxaluria type 1 are variable, but progressive renal failure is prominent and can lead to death in childhood or young adulthood. To facilitate its hepatic uptake, lumasiran is covalently linked to three N-acetylgalactosamine residues which bind to and are taken up by the hepatocyte-specific asialoglycoprotein receptor. Once taken up by cells, the siRNA is cleaved into smaller fragments and separated into single strands that bind and silence the mRNA of HAO1. In animal models, lumasiran reduced HAO1 mRNA levels in liver and oxalate accumulation in liver and kidneys. In small placebo controlled trials of lumasiran in patients with hyperoxaluria, subcutaneous injections resulted in dose related reductions in serum and urinary oxalate levels. With 3 to 6 monthly injections of higher doses, oxalate levels fell by more than 50%. Lumasiran was approved for use in the United States in 2020 for children (12 years of age or older) and adults with primary hyperoxaluria type 1. Indications were subsequently expanded to children of all ages. Lumasiran is available in solution in single dose prefilled syringes of 94.5 mg in 0.5 mL under the brand name Oxlumo. The recommended dose regimen varies by body weight. For patients weighing 20 kg or above, the dose is 3 mg/kg subcutaneously once monthly for 3 months followed by once every 3 months. Administration by a health care provider is recommended. Lumasiran is generally well tolerated but side effects can include injection site reactions, fatigue, arthralgias, diarrhea, abdominal pain, headache, and musculoskeletal pains. In preregistration studies, 5% to 13% of lumasiran treated patients developed anti-drug antibodies, but their presence was not associated with decreased efficacy or safety.

### Hepatotoxicity

In preregistration pivotal trials, lumasiran therapy was well tolerated and minor serum ALT elevations arose in 16% of treated patients and a similar proportion of controls (15%). The elevations were invariably transient, mild-to-moderate in severity, and without accompanying symptoms or jaundice. None of the elevations were above 3 times the upper limit of normal, and none led to drug discontinuation. Since its approval, there have been no published reports of liver injury attributed to lumasiran therapy. Thus, lumasiran is an unlikely cause of clinically apparent liver injury, although it still has had limited widescale clinical use.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The possible cause of hepatic injury from lumasiran or other siRNA therapeutics is not known. Lumasiran, like other siRNA therapeutic agents, is metabolized intracellularly by nucleases and is not a substrate of cytochrome P450 enzymes or hepatic transporters.

### Outcome and Management

Lumasiran has not been linked to significant liver test abnormalities or to clinically apparent liver injury and regular monitoring of routine liver tests is not recommended.

Drug Class: Genetic Disorder Agents, siRNA and Antisense Agents

Other Therapeutic siRNA-based Agent for Hyperoxaluria: Nedosiran

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Lumasiran – Oxlumo®

DRUG CLASS

Genetic Disorder Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Lumasiran)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Lumasiran | 1834610-13-7 (https://pubchem.ncbi.nlm.nih.gov/substance/381128099) | C530-H669-F10-N173-O320-P43-S6-Na43 | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 05 March 2025

Abbreviations: mRNA, messenger RNA; siRNA, small interfering RNA.

FDA. Lumasiran. Integrated Review. 2020. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2020/214103Orig1s000IntegratedR.pdf (The FDA clinical review of lumasiran for efficacy and safety reported from 57 patients, among whom there were no deaths or drug related serious adverse events, injection site reactions arising in 23% [vs none on placebo], ALT elevations arising in 16% [4/44] on lumasiran vs 15% [3/18] on placebo, all ALT elevations were less than 3 times ULN, transient, and not associated with symptoms or jaundice).
Setten RL, Rossi JJ, Han SP. The current state and future directions of RNAi-based therapeutics. Nat Rev Drug Discov 2019; 18: 421-46. (Extensive review of gene silencing using RNA interference pathways and the potential of RNAi therapeutics which have promise in many genetic and acquired diseases including transthyretin amyloidosis [transthyretin], HIV infection [CCR5], HBV [HBV mRNA], alpha-1-antitrypsin deficiency [zz A1AT], hypercholesterolemia [PCSK9]). 30846871
Scott LJ, Keam SJ. Lumasiran: first approval. Drugs. 2021;81(2):277-282. (Review of the mechanism of action, history of development, pharmacology, clinical efficacy and safety of lumasiran shortly after its approval in the US mentions that adverse events of therapy were generally mild and transient, and there were no serious adverse events attributed to lumasiran and no discontinuations or deaths from adverse events). 33405070
Garrelfs SF, Frishberg Y, Hulton SA, Koren MJ, O'Riordan WD, Cochat P, Deschênes G, et al.; ILLUMINATE-A Collaborators. Lumasiran, an RNAi therapeutic for primary hyperoxaluria type 1. N Engl J Med. 2021;384:1216-1226. (Among 39 patients with primary hyperoxaluria type 1 treated with lumasiran or placebo for 6 months, urine and serum oxalate levels decreased with lumasiran therapy and there were no serious adverse events and no clinically relevant changes in liver function tests). 33789010
Frishberg Y, Deschênes G, Groothoff JW, Hulton SA, Magen D, Harambat J, Van't Hoff WG, et al.; study collaborators. Phase 1/2 study of lumasiran for treatment of primary hyperoxaluria type 1: a placebo-controlled randomized clinical trial. Clin J Am Soc Nephrol. 2021;16:1025-1036. (In early phase studies in 32 healthy controls and 20 adult and pediatric patients with primary hyperoxaluria type 1 treated with ascending doses of lumasiran or placebo, adverse events included injection site reactions [38% vs 0%], abdominal pain and headaches which were transient and mild, and there were no drug related serious adverse events or deaths, and no “clinically significant changes in laboratory measures” including liver function tests). 33985991
Hulton SA, Groothoff JW, Frishberg Y, Koren MJ, Overcash JS, Sellier-Leclerc AL, Shasha-Lavsky H, et al. Randomized clinical trial on the long-term efficacy and safety of lumasiran in patients with primary hyperoxaluria type 1. Kidney Int Rep. 2021;7:494-506. (Among 24 patients with primary hyperoxaluria type 1 maintained on lumasiran in an extension study of up to 24 months, improvements in oxalate plasma levels were maintained and nephrocalcinosis scores improved, while adverse events were generally mild [injection stie reactions in 41%, abdominal pain 18%, headaches in 10%] and there were “no clinically relevant changes in laboratory measures” [including liver function tests]). 35257062
Sas DJ, Magen D, Hayes W, Shasha-Lavsky H, Michael M, Schulte I, Sellier-Leclerc AL, et al.; ILLUMINATE-B Workgroup. Phase 3 trial of lumasiran for primary hyperoxaluria type 1: A new RNAi therapeutic in infants and young children. Genet Med. 2022;24:654-662. (Among 18 children less than 6 years of age with primary hyperoxaluria treated with lumasiran for at least 6 months, plasma oxalate decreased by 32% and there were no serious adverse events and only mild injection site reactions [n=2], and “no clinically relevant changes in laboratory measures” including liver tests). 34906487
Michael M, Groothoff JW, Shasha-Lavsky H, Lieske JC, Frishberg Y, Simkova E, Sellier-Leclerc AL, et al. Lumasiran for advanced primary hyperoxaluria type 1: phase 3 ILLUMINATE-C trial. Am J Kidney Dis. 2023;81:145-155.e1. (Among 21 patients with primary hyperoxaluria type 1 treated with lumasiran for at least 6 months, plasma oxalate levels fell by 33-42%, while adverse events were largely mild and transient and included injection site reactions [24%], and there were no “clinically relevant trends” in laboratory measures including liver function tests). 35843439
Hayes W, Sas DJ, Magen D, Shasha-Lavsky H, Michael M, Sellier-Leclerc AL, Hogan J, et al. Efficacy and safety of lumasiran for infants and young children with primary hyperoxaluria type 1: 12-month analysis of the phase 3 ILLUMINATE-B trial. Pediatr Nephrol. 2023; 38:1075-1086. (Further follow up of children with primary hyperoxaluria treated with lumasiran [Sas 2022] for 12 months, found further decreases in plasma oxalate levels [from -32% at 6 months to -47% at 12] and no new adverse events, injection site reactions reported in 3 children [17%] and “no clinically relevant changes in laboratory measures” including liver function tests). 35913563
Ranasinghe P, Addison ML, Dear JW, Webb DJ. Small interfering RNA: Discovery, pharmacology and clinical development–An introductory review. Br J Pharmacol. 2023; 180: 2697-2720. (Review of the history of development, mechanism of action, methods of delivery, clinical efficacy and safety of RNA silencing drugs including lumasiran, givosiran, inclisiran, patisiran and vutrisiran, discusses adverse events from lumasiran of injection site reactions, but does not mention hepatotoxicity or ALT elevations). 36250252
Sellier-Leclerc AL, Metry E, Clave S, Perrin P, Acquaviva-Bourdain C, Levi C, Crop M, et al. Isolated kidney transplantation under lumasiran therapy in primary hyperoxaluria type 1: a report of 5 cases. Nephrol Dial Transplant. 2023;38:517-521. (Among 5 patients with primary hyperoxaluria type 1 and renal failure on hemodialysis who were treated with lumasiran for 5-17 months and the underwent renal transplantation, all survived and had no evidence of recurrence of oxalate renal injury; no mention of hepatotoxicity or ALT elevations). 36307929
Saland JM, Lieske JC, Groothoff JW, Frishberg Y, Shasha-Lavsky H, Magen D, Moochhala SH, et al. Efficacy and safety of lumasiran in patients with primary hyperoxaluria type 1: Results from a phase III clinical trial. Kidney Int Rep. 2024;9:2037-2046. (Among 39 patients with primary hyperoxaluria type 1 treated in a 6 month placebo controlled trial who were then enrolled in an open label long term study, urinary oxalate excretion remained decreased and reached normal levels in 76-92% and kidney stone events declined, while adverse event rates remained low and were mostly injection site reactions; no mention of ALT elevations or hepatotoxicity). 39081738

## OTHER REFERENCE LINKS

1. Recent References on Lumasiran: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Lumasiran/AE)%20AND%20Human%5bMH%5d%20AND%20(drug%20induced%20liver%20injury%20OR%20jaundice/CI%20OR%20bile%20duct%20diseases/CI%20OR%20liver/DE%20OR%20liver%20diseases/CI)%20AND%20(%221900%5C%5C1%5C%5C1%22%5bEDat%5d:%222999%5C%5C12%5C%5C31%22%5bEDat%5d))

2. Trials on Lumasiran: from ClinicalTrials.gov (https://www.clinicaltrials.gov/ct2/results?term=Lumasiran)